# Clonazepam

## OVERVIEW

### Introduction

Clonazepam is a benzodiazepine used predominantly as an anticonvulsant as adjunctive therapy in management of epilepsy. Therapy with clonazepam is not associated with serum aminotransferase elevations, and clinically apparent liver injury from clonazepam, if it occurs at all, must be exceedingly rare.

### Background

Clonazepam (kloe naz' e pam) is a benzodiazepine with particularly potent activity against spread of seizure activity in several animal models. The antiseizure activity of the benzodiazepines is mediated by their ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission through binding to the GABA A receptor. Clonazepam was approved in the United States for treatment of epilepsy in 1997 and currently more than 20 million prescriptions are filled yearly. Clonazepam is currently indicated for management of absence seizures and myoclonic seizures in children as well as generalized seizure disorders in both adults and children. Clonazepam is effective in status epilepticus, but diazepam and lorazepam are preferable because of their longer half lives. Clonazepam is also used for restless leg syndrome, dysarthria, tic disorders, panic disorder and acute mania. Clonazepam is available in generic forms and under the brand name Klonopin in tablets of 0.5, 1.0 and 2 mg as well as in orally disintegrating tablets for pediatric use. The recommended initial dose for adults is 1.5 mg daily in three divided doses, increasing as needed to a maximum dose of 20 mg daily. The most common side effects of clonazepam are dose related and include drowsiness, lethargy, ataxia, dysarthria and dizziness. Tolerance develops to these side effects, but tolerance may also develop to the antiseizure effects.

### Hepatotoxicity

Clonazepam, as with other benzodiazepines, is rarely associated with serum ALT elevations, and clinically apparent liver injury from clonazepam is extremely rare. However, at least one convincing case report of acute liver injury from clonazepam with recurrence on reexposure has been reported. Rare instances of drug induced liver injury has been reported with other benzodiazepines, such as chlordiazepoxide, diazepam, flurazepam, triazolam, clorazepate and alprazolam. In benzodiazepine related cases of acute liver injury, the latency has ranged from a few weeks to 6 months; the typical pattern of liver enzyme elevations has been cholestatic or mixed, but hepatocellular patterns have also been reported. The injury is usually mild to moderate in severity and self-limited. Fever and rash have not been described nor has autoantibody formation.

Likelihood score: D (possible but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The liver injury from benzodiazepines is probably due to a rarely produced intermediate metabolite. Their relative safety may relate to the low daily doses used (typically 5 to 10 mg).

### Outcome and Management

The case reports of hepatic injury due to clonazepam were followed by complete recovery, without evidence of residual or chronic injury. No cases of acute liver failure or chronic liver injury due to clonazepam have been described. There is no information about cross reactivity with other benzodiazepines (clobazam, clorazepate, lorazepam or diazepam), but some degree of cross sensitivity should be assumed.

Drug Class: Anticonvulsants, Benzodiazepines

## CASE REPORTS

### Case 1. Cholestatic hepatitis due to flurazepam.

[Modified from: Fang MH, Ginsberg AL, Dobbins WO 3rd. Cholestatic jaundice associated with flurazepam hydrochloride. Ann Intern Med 1978; 89: 363-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/28685)]

A 70 year old man developed anorexia, weakness and fatigue 2 months after starting flurazepam for insomnia. Two and a half months later he developed dark urine and jaundice. He had no previous history of liver disease, risk factors for acquiring hepatitis and drank no alcohol. He had coronary artery disease, angina pectoris and type 2 diabetes for which he took chlorthalidone, isosorbide dintitrate, digoxin and tolbutamide chronically. On admission he was jaundiced, but had no fever or rash. Liver tests, which had been normal before starting flurazepam, were elevated (Table). Ultrasound of the abdomen was unremarkable, HBsAg was negative, and a percutaneous cholangiogram was normal. A liver biopsy showed intrahepatic cholestasis. Flurazepam was stopped and liver tests improved, although pruritus did not resolve for four months. The other medications were apparently continued.

#### Key Points

Medication: | Flurazepam (30 mg orally as needed)
Pattern: | Mixed→Cholestatic (R=2.4→1.8)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 months until nausea, 4.5 months to jaundice
Recovery: | Complete recovery 2 months after stopping
Other medications: | Isosorbide dinitrate, chlorthalidone, digoxin, tolbutamide

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 40 | 90 | 0.5
0 | Flurazepam started
4.5 months | | 225 | 207 | 7.0
5 months | 0 | 159 | 232 | 6.6
| Flurazepam stopped
| 4 days | 174 | 230 | 5.0
| 7 days | 181 | 225 | 4.5 | Liver biopsy
| 24 days | 79 | 183 | 1.7
6 months | 4 weeks | 59 | 142 | 1.0
6.5 months | 7 weeks | 47 | 104 | 0.6
Normal Values | | <49 | <90 | <1.2

#### Comment

Cholestatic hepatitis arising after 4 months of intermittent use of flurazepam. Other possible causes were tolbutamide, but the liver injury resolved despite it being continued. Mild self-limited cholestatic hepatitis is the typical pattern of benzodiazepam induced acute liver injury, but it is very rare and has not been associated with acute liver failure or chronic liver injury.

### Case 2. Cholestatic hepatitis due to flurazepam.

[Modified from: Reynolds R, Lloyd DA, Slinger RP. Cholestatic jaundice induced by flurazepam hydrochloride. Can Med Assoc J 1981; 124: 893-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7214289)]

A 44 year old Dutch woman visiting relatives in Canada developed anorexia, nausea and abdominal discomfort. She had been taking flurazepam for insomnia intermittently for 6 months, but more frequently while visiting. After developing jaundice and pruritis, she was admitted for evaluation. She had no previous history of liver disease, risk factors for acquiring hepatitis and drank little alcohol. She took no other medications. She was jaundiced but had no fever, rash or signs of chronic liver disease. Liver tests were elevated (Table). Ultrasound of the abdomen was unremarkable and HBsAg was negative. A liver biopsy showed intrahepatic cholestasis. Flurazepam was stopped and liver tests improved rapidly.

#### Key Points

Medication: | Flurazepam (30 mg orally as needed)
Pattern: | Mixed (R=2.5)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 6 months to onset of symptoms
Recovery: | Complete recovery one month after stopping
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
6 months | 0 | 106 | 209 | 8.2 | 8% eosinophils
| 1 day | 122 | 203 | 8.3
| 3 days | 134 | 201 | 7.2 | Liver biopsy
| 6 days | 185 | 195 | 6.6
| 17 days | 108 | 121 | 2.0
| 4 weeks | 60 | 111 | 1.8
7 months | 7 weeks | 16 | 96 | 1.0
Normal Values | | <24 | <120 | <1.2

#### Comment

The benzodiazepines are widely used agents for therapy of anxiety, insomnia, tremor and some forms of seizures. They are extremely well tolerated and only rarely associated with significant liver injury. This case is typical of the rare instances of hepatotoxicity reported with benzodiazepines, marked by a self-limited cholestatic hepatitis arising after several months of use. Signs of hypersensitivity or autoimmunity are uncommon, although this patient had mild eosinophilia. Liver enzymes were only modestly elevated and the calculated R value suggested that the pattern of injury was “mixed.” However, the prominence of jaundice and pruritis along with the liver biopsy findings indicate that the injury was predominantly cholestatic.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clonazepam – Klonopin®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clonazepam | 1622-61-3 | C15-H10-Cl-N3-O3 | Clonazepam chemical structure

## REFERENCES

References updated: 25 January 2017

Zimmerman HJ. Benzodiazepines. Psychotropic and anticonvulsant agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 491-3. (Expert review of benzodiazepines and liver injury published in 1999; mentions rare instances of cholestatic hepatitis have been reported due to alprazolam, chlordiazepoxide, clonazepam, diazepam, flurazepam, and triazolam, and hepatocellular injury with clorazepate, but no reports of hepatic injury with lorazepam, oxazepam or temazepam).
Larrey D, Ripault M-P. Benzodiazepines. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 455. (Review of drug induced liver injury mentions that there have been rare instances of acute liver injury [usually cholestatic] reported with alprazolam, bentazepam, chlordiazepoxide, clonazepam, clorazepate, clotiazepam, diazepam, flurazepam, and triazolam; a hepatitis-like pattern was reported with alprazolam and diazepam).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; benzodiazepines are not discussed).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-607. (Textbook of pharmacology and therapeutics).
Mihic SJ, Harris RA. Hypnotics and sedatives. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 457-80. (Textbook of pharmacology and therapeutics).
Parker JLW. Potassium clorazepate (Tranxene)-induced jaundice. Postgrad Med J 1979; 55: 908-10. (27 year old man developed jaundice, pruritus and fever, 2 months after starting clorazepate [bilirubin 7.6 mg/dL, ALT 880 U/L, Alk P 2.3 times ULN] and had 3 liver biopsies done over 5 months showing intrahepatic cholestasis with thin portal-portal fibrosis septae that persisted as cholestasis and inflammation resolved). 44913
Bonkowsky HL, Sinclair PR, Emery S, Sinclair JF. Seizure management in acute hepatic porphyria: risks of valproate and clonazepam. Neurology 1980; 30: 588-92. (38 year old man with acute intermittent porphyria and seizures did not respond to clonazepam, and testing in chicken embryos showed that it increased hepatic prophyrins and ALA synthase activity). 6770287
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (Among 572 cases of hepatotoxicity reported to a Danish registry between 1968 and 1978, 97 were due to psychotropic agents, but only two attributed to benzodiazepines). 6982502
Keränen T, Sivenius J. Side effects of carbamazepine, valproate and clonazepam during long-term treatment of epilepsy. Acta Neurol Scand Suppl 1983; 97: 69-80. (Clonazepam has many dose related sedative side effects, but compared to carbamazepine and valproate, few serious or long term side effects; no mention of hepatic side effects of clonazepam). 6424398
Davion T, Capron-Chivrac D, Andrejak M, Capron JP. [Hepatitis due to antiepileptic agents] Gastroenterol Clin Biol 1985; 9: 117-26. (Review of hepatotoxicity of anticonvulsants; among benzodiazepines, cases of cholestatic hepatitis have been linked to chlordiazepoxide and diazepam, but liver injury from this class of drugs is rare). 3920108
Olsson R, Zettergren L. Anticonvulsant-induced liver damage. Am J Gastroenterol 1988; 83: 576-7. (30 year old man developed fever, rash and jaundice 6 weeks after starting phenytoin; he was switched to carbamazepine and clonazepam, but redeveloped jaundice 3 months later; resolved with stopping, but recurred with restarting clonazepam alone [bilirubin 1.8 mg/dL, ALT 1380 U/L, Alk P 176 U/L] without rash, fever or eosinophilia; resolving in 6 weeks of stopping clonazepam). 3364416
Suzuki A, Aso K, Ariyoshi C, Ishimaru M. Acute intermittent porphyria and epilepsy: safety of clonazepam. Epilepsia 1992; 33: 108-11. (13 year old girl with acute intermittent porphyria worsened on valproate and on phenytoin therapy, but clonazepam led to control of seizures and no worsening of porphyria). 1733741
Wallace SJ. A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf 1996; 15: 378-93. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine; “No child taking… benzodiazepines had raised liver enzyme levels,”). 8968693
Lewis JH, Zimmerman HJ. Drug- and chemical-induced cholestasis. Clin Liver Dis 1999; 3: 433-64, vii. (Review of drug induced cholestatic syndromes, listing many causes including chlordiazepoxide and flurazepam; “Benzodiazepines may cause cholestatic injury, although this is rare”). 11291233
Selim K, Kaplowitz N. Hepatotoxicity of psychotropic drugs. Hepatology 1999; 29: 1347-51. (Review of hepatotoxicity of phenothiazines, butyrophenones, tricyclics, MAO inhibitors, acetylcholesterase inhibitors, and psychotropic drugs of abuse; “benzodiazepines…have a very low hepatotoxic potential, with only case reports in the literature, usually with a cholestatic pattern). 10216114
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 10 were attributed to phenytoin, 10 to valproate and 1 to carbamazepine, but none to benzodiazepines). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs, of which 1 was attributed to phenytoin, 1 to valproate and 1 to carbamazepine, but none to benzodiazepines). 16165719
Gil-Martin A, Saez-Royuela F, Arias L, Angulo ML, Nogal B. [Hepatic fibrosis after antidepressant treatment] Rev Esp Enferm Dig 2005; 97: 461-2. Spanish. (32 year old woman developed pruritis and jaundice 1-2 months after starting sertraline, aprazolam and clorazepate, resolving with stopping sertraline, but had persistent minor ALT elevations and biopsy showing mild bridging fibrosis 4 months later). 16048430
Andrade RJ, Lucena MI, Kaplowitz N, García-Muņoz B, Borraz Y, Pachkoria K, García-Cortés M, et al. Outcome of acute idiosyncratic drug-induced liver injury: Long-term follow-up in a hepatotoxicity registry. Hepatology. 2006; 44: 1581-8. (28 of 493 [5.7%] cases of drug induced liver disease had evidence of chronicity, including 3 cases due to bentazepam and one with clorazepate, the latter with recovery at 25 months). 17133470
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 20 were attributed to benzodiazepines including 5 for clorazepate, 5 alprazolam, 6 lorazepam and 4 diazepam, but compared to controls, relative risk of injury was increased only for clorazepate [8.3: estimated frequency 3.4 per 100,000 person-year exposures]). 17539979
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to a benzodiazepine). 18955056
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand 2008; 118: 281-90. (Review of hepatotoxicity of all anticonvulsants focusing upon phenytoin, valproate, carbamazepine; “Furthermore, hepatoxicity has not been convincingly shown to be associated with the use of benzodiazepines”). 18341684
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; benzodiazepines were not among the top 40 agents implicated). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to benzodiazepine use). 20949552
Wick JY. The history of benzodiazepines. Consult Pharm 2013; 28: 538-48. (History of the development, approval, widescale use and eventual restriction and decrease in use of the benzodiazepines). 24007886
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants including clonazepam; no mention of hepatotoxicity). 23348233
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were linked to benzodiazepines). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to a benzodiazepine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none to benzodiazepine anticonvulsants). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Clonazepam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(clonazepam/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/01%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Clonazepam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=clonazepam)